# Dabigatran

## OVERVIEW

### Introduction

Dabigatran is a direct inhibitor of thrombin and anticoagulant which is used for prevention of stroke and venous embolism in patients with chronic atrial fibrillation. Dabigatran therapy has been associated with a low rate of serum enzyme elevations and rare instances of liver enzyme elevations and jaundice.

### Background

Dabigatran (da" bi gat' ran) is a potent direct inhibitor of thrombin, the final intermediate in blood coagulation. Dabigatran binds to the active site of thrombin and inactivates both fibrin-bound and unbound thrombin, unlike heparin that binds to the unbound thrombin only. Inhibiting thrombin prevents the conversion of fibrinogen to fibrin and subsequent cross linking of fibrin monomers, platelet activation and amplification of coagulation activation. Dabigatran itself is not absorbed from the gastrointestinal tract, but the prodrug dabigatran etexillate mesylate is absorbed and then converted to the active form by gut and plasma esterases. Dabigatran provides a reliable anticoagulant effect and monitoring of effect is not needed. Dabigatran etexilate was approved for use in the United States in 2010 and indications are for prevention of stroke and thromboembolic complications in patients with chronic atrial fibrillation not related to valvular heart disease. Thereafter, indications were extended to the treatment and prevention of deep venous thrombosis and pulmonary embolism. Dabigatran is available in capsules of 75 and 150 mg under the brand name Pradaxa and the recommended dose in adults is 75 to 150 mg twice daily. Dabigatran, like other anticoagulants, is associated with bleeding adverse events, but these are not common and no more frequent than with low molecular weight heparins or warfarin. Side effects not directly attributable to the anticoagulant activity are not common but can include nausea, abdominal discomfort, diarrhea, anorexia, fever, and skin rash. Rare, potentially severe adverse events include serious and fatal bleeding.

### Hepatotoxicity

Chronic therapy with dabigatran is associated with moderate ALT elevations (greater than 3 times the upper limit of normal) in 1.5% to 3% of patients, an overall rate which is slightly lower than with low molecular weight heparin and similar to the rates with warfarin. While case reports of clinically apparent liver injury due to dabigatran have not been published, several instances of ALT elevations with jaundice occurred during the large, prelicensure clinical trials of dabigatran. These cases were mild and self-limited, resolving completely once therapy was stopped. However, other causes of liver injury could not always be identified and the relationship of the injury to dabigatran therapy remains unclear. The clinical features of these cases were not described. In one large clinical trial, these unexplained cases of liver injury with bilirubin elevations occurred in approximately 1 in 2000 patients treated. In a subsequent case report, liver injury with jaundice and a mixed pattern of serum enzyme elevations arose within 4 weeks of starting dabigatran and resolved rapidly with its discontinuation. Immunoallergic and autoimmune features were not present. There have been multiple spontaneous reports of liver injury, some of which were fatal, made to WHO and FDA surveillance databases, but the relatedness of the episodes has not been clearly defined. Thus, clinically apparent liver injury with jaundice due to dabigatran occurs but is rare and typically mild and self-limited.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

One reason why dabigatran was subjected to close scrutiny for evidence of hepatotoxicity was that the initial oral, direct thrombin inhibitor developed and evaluated in clinical trials was ximelagatran (zye" mel a gat' ran), which subsequently was found to be associated with rare but potentially severe cases of liver injury, typically arising after 1 to 6 months of treatment with a hepatocellular pattern of serum enzyme elevations and potentially severe and fatal course. Ximelagatran did not receive approval for use in the United States because of concerns about hepatotoxicity. After several further cases of clinically apparent hepatic injury were found in patients taking ximelagatran, it was also withdrawn from use in Europe. Risk of serum ALT elevations during ximelagatran therapy were later shown to be linked to HLA-DRB1*07 and DQA1*-02.

### Mechanism of Injury

The cause of liver injury during dabigatran oral anticoagulant therapy is unknown but is likely to be idiosyncratic and perhaps immunologic. Dabigatran undergoes little hepatic metabolism and does not affect CYP 450 activity.

### Outcome and Management

Liver injury attributed to dabigatran varies from mild serum ALT elevations to liver injury with jaundice, but is usually mild and self-limited, resolving within 4 weeks of stopping. Recurrence of liver injury with rechallenge has not been described. There is no reason to suspect that there is cross sensitivity to hepatic injury among the different anticoagulants.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants, Thrombin Inhibitors: Desirudin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dabigatran – Pradaxa®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dabigatran)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dabigatran Etexilate | 211914-51-1 | C25-H25-N7-O3 | Dabigatran Etexilate Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 November 2017

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-412. (Textbook of hepatotoxicity published in 1999 before the availability of dabigatran or ximelagatran).
Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Albers GW, Diener HC, Frison L, Grind M, Nevinson M, Partridge S, Halperin JL, et al; SPORTIF Executive Steering Committee for the SPORTIF V Investigators. Ximelagatran vs warfarin for stroke prevention in patients with nonvalvular atrial fibrillation: a randomized trial. JAMA 2005; 293: 690-8. (Controlled trial of ximelagatran versus warfarin for stroke prevention for an average of 20 months in 3922 patients with atrial fibrillation found ALT elevations above 3 times ULN in 0.8% of warfarin, but 6% of ximelagatran treated subjects; while these abnormalities often resolved even with continuing treatment, 8 subjects also had bilirubin elevations, one died of acute liver failure and one of gastrointestinal hemorrhage). 15701910
Lee WM, Larrey D, Olsson R, Lewis JH, Keisu M, Auclert L, Sheth S. Hepatic findings in long-term clinical trials of ximelagatran. Drug Saf 2005; 28: 351-70. (Retrospective, expert analysis of hepatotoxicity of ximelagatran based upon results from 6230 patients in clinical trials; elevations in ALT above 3 times ULN occurred in 7.9% of ximelagatran treated vs 1.2% in comparator arms, usually within 1 to 6 months of starting, resolving within a few weeks of stopping, and not usually recurring upon reexposure [6%]; 0.5% had elevations in both ALT and bilirubin, and one had severe hepatitis and died possibly of a complication of corticosteroid treatment). 15783243
Kindmark A, Jawaid A, Harbron CG, Barratt BJ, Bengtsson OF, Andersson TB, Carlsson S, et al. Genome-wide pharmacogenetic investigation of a hepatic adverse event without clinical signs of immunopathology suggests an underlying immune pathogenesis. Pharmacogenomics J 2008; 8: 186-95. (Genome-wide analysis of 74 patients who developed serum ALT elevations during ximelagatran therapy and 130 who did not in prelicensure clinical trials, found an association of liver injury with HLA-DRB1*07 [present in 26% of cases vs 8.5% of controls]). 17505501
Eriksson BI, Dahl OE, Rosencher N, Kurth AA, van Dijk CN, Frostick SP, Prins MH, et al.; RE-NOVATE Study Group. Dabigatran etexilate versus enoxaparin for prevention of venous thromboembolism after total hip replacement: a randomised, double-blind, non-inferiority trial. Lancet 2007; 370: 949-56. (Controlled trial of dabigatran vs enoxaparin in 3294 patients undergoing hip replacement found ALT elevations above 3 times ULN in 3% of dabigatran vs 5% of enoxaparin treated patients, all returning to baseline during follow up; 2 dabigatran treated patients had elevations in ALT and bilirubin, diagnosis being cholangitis in one and unknown in other, both resolving with discontinuation). 17869635
Eriksson BI, Dahl OE, Rosencher N, Kurth AA, van Dijk CN, Frostick SP, Kälebo P, et al.; RE-MODEL Study Group. Oral dabigatran etexilate vs. subcutaneous enoxaparin for the prevention of venous thromboembolism after total knee replacement: the RE-MODEL randomized trial. J Thromb Haemost 2007; 5: 2178-85. (Controlled trial of dabigatran vs enoxaparin in 2076 patients undergoing knee replacement surgery found ALT elevations above 3 times ULN in 2.8% to 3.7% of dabigatran vs 4.0% of enoxaparin treated subjects; one patient on dabigatran had a simultaneous elevation of bilirubin and ALT which was unexplained and resolved within 4 weeks of stopping). 17764540
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver injury in the US collected from 2004 to 2008, none were attributed to warfarin or other anticoagulants). 18955056
Schulman S, Kearon C, Kakkar AK, Mismetti P, Schellong S, Eriksson H, Baanstra D, et al.; RE-COVER Study Group. Dabigatran versus warfarin in the treatment of acute venous thromboembolism. N Engl J Med 2009; 361: 2342-52. (Controlled trial of dabigatran vs warfarin for 6 months in 1274 patients with venous thromboses; ALT levels >3 times ULN occurred in 3.4% of dabigatran vs 3.8% of warfarin treated patients, and 6 patients had both a bilirubin and ALT elevations, but all had another plausible reason for liver injury [cancer, cholangitis]). 19966341
Connolly SJ, Ezekowitz MD, Yusuf S, Eikelboom J, Oldgren J, Parekh A, Pogue J, et al.; RE-LY Steering Committee and Investigators. Dabigatran versus warfarin in patients with atrial fibrillation. N Engl J Med 2009; 361: 1139-51. (Controlled trial of dabigatran vs warfarin in 18,113 patients with atrial fibrillation for average of 2 years found ALT above 3 times ULN in 1.9-2.1% of dabigatran vs 2.2% of warfarin treated subjects; 0.2% in both groups had simultaneous bilirubin and ALT elevations). 19717844
Dabigatran etexilate (Pradaxa)--a new oral anticoagulant. Med Lett Drugs Ther 2010; 52 (1351): 89-90. (Concise review of pharmacology, efficacy and safety of dabigatran shortly after its approval in the US; most common troublesome side effects are dyspepsia and gastritis; no mention of liver injury or hepatotoxicity). 21068702
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, but none were due to anticoagulants or platelet inhibitors). 20949552
Friedman RJ, Dahl OE, Rosencher N, Caprini JA, Kurth AA, Francis CW, Clemens A, et al.; RE-MOBILIZE, RE-MODEL, RE-NOVATE Steering Committees. Dabigatran versus enoxaparin for prevention of venous thromboembolism after hip or knee arthroplasty: a pooled analysis of three trials. Thromb Res 2010; 126: 175-82. (Analysis of 3 trials of prevention of venous thrombosis after arthroplasty found ALT elevations >3 times ULN in 2.2 to 2.6% of dabigatran vs 3.6% of enoxaparin treated subjects, usually arising in first 10 days; 2 of 5270 [~1 per 2000] dabigatran treated patients had both jaundice and enzyme elevations without another obvious cause, both resolving on stopping dabigatran). 20434759
Tran A, Cheng-Lai A. Dabigatran etexilate: the first oral anticoagulant available in the United States since warfarin. Cardiol Rev 2011; 19: 154-61. (Review of pharmacology, safety and efficacy of dabigatran; "unlike ximelagatran, dabigatran does not appear to have any hepatotoxic effects," ALT elevations greater than 3 times ULN occurred in 3% of treated patients). 21464643
Hankey GJ, Eikelboom JW. Dabigatran etexilate: a new oral thrombin inhibitor. Circulation 2011; 123: 1436-50. (Review of the mechanism of action, pharmacokinetics, clinical efficacy and safety of dabigatran). 21464059
Nutescu E, Chuatrisorn I, Hellenbart E. Drug and dietary interactions of warfarin and novel oral anticoagulants: an update. J Thromb Thrombolysis 2011; 31: 326-43. (Extensive review of the drug-drug and drug-food interactions of the oral anticoagulants; unlike with warfarin, there are few significant drug and dietary interactions with dabigatran). 21359645
Ma TK, Yan BP, Lam YY. Dabigatran etexilate versus warfarin as the oral anticoagulant of choice? A review of clinical data. Pharmacol Ther 2011; 129: 185-94. (Review of trials of efficacy and safety of dabigatran mentions that ALT levels above 3 times ULN occurred in 1.5-3.1% of dabigatran vs 5-7.4% of enoxaparin treated patients). 20920530
Eriksson BI, Dahl OE, Huo MH, Kurth AA, Hantel S, Hermansson K, Schnee JM, et al.; RE-NOVATE II Study Group. Oral dabigatran versus enoxaparin for thromboprophylaxis after primary total hip arthroplasty (RE-NOVATE II*). A randomised, double-blind, non-inferiority trial. Thromb Haemost 2011; 105: 721-9. (Controlled trial of dabigatran vs enoxaparin in 2055 patients undergoing orthopedic surgery found similar efficacy and side effects of the 2 anticoagulants; ALT elevations above 3 times ULN occurred in 3.8% on dabigatran and 5.6% on enoxaparin, and there were no episodes of clinically apparent liver injury that could be linked to either). 21225098
Rochwerg B, Xenodemetropoulos T, Crowther M, Spyropoulos A. Dabigatran-induced acute hepatitis. Clin Appl Thromb Hemost 2012; 18: 549-50. (71 year old man with atrial fibrillation developed jaundice 2-4 weeks after starting dabigatran [bilirubin 6.0 mg/dL, ALT 667 U/L, Alk P 680 U/L], resolving within 2 weeks of stopping). 22962308
Fulcrand J, Lerooy A, Giraud J, Cailliau A, Delrot C, Petitpain N, Auffret M; le réseau des Centres régionaux de Pharmacovigilance. [Cytolysis in an elderly patient treated with dabigatran etexilate]. Therapie 2013; 68: 332-4. (86 year old woman with atrial fibrillation was taking dabigatran for 6 months when she presented with renal failure and ALT elevations [100 times ULN; bilirubin and Alk P not mentioned], which fell to normal within days of stopping). 24225047
Caldeira D, Barra M, Santos AT, de Abreu D, Pinto FJ, Ferreira JJ, Costa J. Risk of drug-induced liver injury with the new oral anticoagulants: systematic review and meta-analysis. Heart 2014; 100: 550-6. (Systemic review of controlled trials of newer anticoagulants identified 29 trials in 152,116 patients followed for an average of 16 months and found no increase in risk of ALT elevations above 3 times ULN compared to low molecular weight heparin or placebo arms; 2.1% taking dabigatran vs 2.7% in control groups). 24476812
New oral anticoagulants for acute venous thromboembolism. Med Lett Drugs Ther 2014; 56 (1433): 3-4. (Brief comparison of warfarin, rivaroxaban, apixaban and dabigatran as anticoagulants as therapy for venous thromboembolism, all of which have similar efficacy, warfarin requiring regular monitoring of INR whereas the others not). 24419296
Raschi E, Poluzzi E, Koci A, Salvo F, Pariente A, Biselli M, Moretti U, et al. Liver injury with novel oral anticoagulants: assessing post-marketing reports in the US Food and Drug Administration adverse event reporting system. Br J Clin Pharmacol 2015; 80: 285-93. (Analysis of 17,097 reports to FDA on adverse events associated with newer oral anticoagulants identified 146 liver related events attributed to rivaroxaban [3.7% of total reports] with 25 resulting in acute liver failure, and 222 to dabigatran [1.7% of total] with 41 resulting in acute liver failure; case-by-case analysis was difficult "it should be acknowledged that this clinical event may not be necessarily related to the drug"). 25689417
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients With drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 patients with clinically apparent drug induced liver injury enrolled in a US prospective study over an 8 year period, 2 were attributed to antithrombotic agents including 1 to prasurgel [platelet inhibitor] and 1 to dalteparin [low molecular weight heparin], but none to dabigatran). 25754159
Liakoni E, Rätz Bravo AE, Krähenbühl S. Hepatotoxicity of new oral anticoagulants (NOACs). Drug Saf 2015; 38: 711-20. (Systematic review of evidence of hepatotoxicity of new oral anticoagulants includiing rivaroxaban, apixaban, edoxaban and dabigatran found 22 cases of liver injury due to rivaroxaban, 2 dabigatran, 2 apixaban, but none to endoxaban). 26138527
Alonso A, MacLehose RF, Chen LY, Bengtson LG, Chamberlain AM, Norby FL, Lutsey PL. Prospective study of oral anticoagulants and risk of liver injury in patients with atrial fibrillation. Heart 2017; 103: 834-9. (Analysis of a database on more than 1 million patients with nonvalvular atrial fibrillation on oral anticoagulants identified 960 hospitalizations with liver injury, rates being highest for warfarin, intermediate for rivaroxaban, and lowest for apixaban and dabigatran). 28057799
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of hepatotoxicity of recently approved medications including dabigatran which has been implicated in cases of clinically apparent liver injury in both FDA and WHO spontaneous reporting databases, including 41 instances of acute liver failure). 27842767

## OTHER REFERENCE LINKS

1. Recent References on Dabigatran Etexilate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Dabigatran+Etexilate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dabigatran Etexilate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dabigatran+Etexilate)